# Danicopan

## OVERVIEW

### Introduction

Danicopan is an orally available complement Factor D inhibitor that is used together with C5 inhibitors (ravulizumab or eculizumab) to treat the hemolytic anemia of paroxysmal nocturnal hemoglobinuria (PNH). Danicopan is associated with a moderate rate of serum aminotransferase elevations during treatment, but it has not been linked to instances of clinically apparent liver injury.

### Background

Danicopan (dan" i koe' pan) is a small-molecule, orally available inhibitor of complement Factor D, the serine protease that cleaves Factor B to form the alternative-pathway to Complement Factor 3 [C3] convertase. By blocking the alternative pathway, danicopan inhibits the C3-mediated destruction of red cells outside blood vessels (extravascular hemolysis) that can persist in PNH despite control of intravascular hemolysis by C5 inhibitors. Danicopan was approved for use in the United States in 2024 as an add on therapy in adults already receiving ravulizumab or eculizumab; it has not been shown to be effective as monotherapy. Danicopan is available in tablets of 50 mg and 100 mg under the brand name Voydeya. The usual adult dose is 150 mg three times daily, increased to 200 mg three times daily if needed. Because inhibiting the alternative complement pathway raises the risk of serious infection with encapsulated bacteria, danicopan carries a boxed warning and is available only through a restricted distribution program that requires vaccination against meningococcal, pneumococcal, and Haemophilus influenzae type B infection before starting the drug. Common side effects include headache, cough, upper respiratory tract infection, nausea, vomiting, and increases in blood pressure and serum triglycerides. Potential severe adverse events include cholecystitis, severe infections, systemic arterial hypertension, pancreatitis, and pains in the extremities.

### Hepatotoxicity

In the pre-registration trials, serum aminotransferase elevations were more common with danicopan than with placebo treatment, but the elevations were usually transient, asymptomatic, and not accompanied by jaundice. In the large placebo-controlled trial, ALT rose above 3 times the upper limit of normal (ULN) in 14% of danicopan-treated patients vs 3% of placebo-recipients and above 5 times ULN in 7% vs none. In long-term extension studies discontinuations because of ALT or AST elevations were uncommon and no instance of clinically apparent liver injury occurred. Breakthrough hemolysis typically accompanied the ALT and AST elevations and may have accounted for the episodes that led to drug discontinuations. Nevertheless, monitoring of liver tests is recommended before and during treatment. Since the approval of danicopan and its more widespread use, there have been no reports of clinically apparent liver injury attributed to its use, but PNH is a rare disease and clinical experience with danicopan has been limited.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the aminotransferase elevations seen with danicopan is not known. They may reflect a mild, adaptive hepatic response to the drug or its metabolism, and concurrent breakthrough hemolysis can confound the picture. Danicopan is metabolized in the liver and inhibits the drug transporters BCRP and P-glycoprotein, which can raise concentrations of co-administered substrates of those transporters.

### Outcome and Management

The aminotransferase elevations associated with danicopan are usually mild to moderate in severity and with drug withdrawal but can also resolve on continued treatment. No cases of severe or prolonged liver injury have been linked to danicopan therapy. The product label recommends monitoring of liver tests before and during treatment, with interruption or discontinuation if elevations are persistent or are associated with jaundice or symptoms. Because the aminotransferase and bilirubin rises can be difficult to separate from those of ongoing hemolysis, a rising pattern out of proportion to hemolytic markers should prompt evaluation for drug-induced injury.

Drug Class: Hematological Agents

Other Drugs in the Subclass: Eculizumab, Ravulizumabi

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Danicopan – Voydeya®

DRUG CLASS

Hematological Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Danicopan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Danicopan | 1903768-17-1 | C26H23BrFN7O3 | SID: 394299886

## ANNOTATED BIBLIOGRAPHY

References updated: 07 September 2026

Abbreviations used: ULN, upper limit of normal; PNH, paroxysmal nocturnal hemoglobinuria; EVH, extravascular hemolysis.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of oral complement inhibitors such as danicopan).
Drugs@FDA: FDA-Approved Drugs https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/218037Orig1s000TOC.html
(FDA website with product label and Integrated Review of data on efficacy and safety of danicopan submitted by the sponsor in support of its approval for use in paroxysmal nocturnal hemoglobinuria (PNH), mentions that serum ALT levels rose to above 3 times ULN in 14% of danicopan- vs 3% of placebo-recipients and were above 5 times ULN in 7% vs none, while bilirubin was raised in the majority of patients and was less likely raised in those on danicopan [47%] than placebo [65%] probably reflecting red cell hemolysis rather than liver dysfunction; 2 cases of possible drug-induced liver injury were identified but both had potential alternative causes).
Risitano AM, Kulasekararaj AG, Lee JW, Maciejewski JP, Notaro R, Brodsky R, Huang M, et al. Danicopan: an oral complement factor D inhibitor for paroxysmal nocturnal hemoglobinuria. Haematologica. 2021;106:3188-3197. 33121236
(In a dose-finding study of danicopan monotherapy [100 to 200 mg 3 times daily] in 10 untreated patients with PNH, mean hemoglobin levels rose from a 9.8 to 11.5 g/dL by day 84, while one patient had ALT and AST elevations that led to early drug withdrawal).
Kulasekararaj AG, Risitano AM, Maciejewski JP, Notaro R, Browett P, Lee JW, Huang M, et al. Phase 2 study of danicopan in patients with paroxysmal nocturnal hemoglobinuria with an inadequate response to eculizumab. Blood. 2021;138:1928-1938. 34314483
(In a dose-finding study of danicopan [100 to 200 mg 3 times daily] added to eculizumab for 24 weeks in 12 patients with PNH, mean hemoglobin levels rose from 7.9 to 10.3 g/dL and transfusion needs fell, while adverse events included headache, cough, abdominal pain, fatigue, and nausea, and one patient had concurrent bilirubin and ALT elevations that were transient, asymptomatic, and resolved without dose interruption).
Lee JW, Griffin M, Kim JS, Lee Lee LW, Piatek C, Nishimura JI, Carrillo Infante C, et al. Addition of danicopan to ravulizumab or eculizumab in patients with paroxysmal nocturnal haemoglobinuria and clinically significant extravascular haemolysis (ALPHA): a double-blind, randomised, phase 3 trial. Lancet Haematol. 2023;10:e955-e965. 38030318
(In a controlled trial of adding danicopan vs placebo to ravulizumab or eculizumab therapy in 63 patients with PNH, hemoglobin levels improved more with danicopan [from 7.7 to 10.8 vs 7.7 to 8.5 g/dL by week 12] while ALT elevations arose in 2 patients leading to discontinuation, but no patient had concurrent ALT and bilirubin elevations or met criteria for clinically apparent liver injury).
Kulasekararaj AG, Griffin M, Piatek CI, Shammo J, Nishimura JI, Patriquin C, Schrezenmeier H, et al. Long-term efficacy and safety of danicopan as add-on therapy to ravulizumab or eculizumab in PNH with significant EVH. Blood. 2025;145:811-822. 39700502
(In a long-term extension study of the controlled trial of adding danicopan to ravulizumab or eculizumab in 84 patients with PNH [Lee 2023], improvements in hemoglobin levels were sustained for up to 72 weeks and no new safety signals were observed, although 6 patients discontinued therapy permanently because of liver test abnormalities, these arose mostly during the first 6 months and only 1 during the extension period).

## OTHER REFERENCE LINKS

1. Recent References on Danicopan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Danicopan%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Danicopan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Danicopan)